# Dacarbazine

## OVERVIEW

### Introduction

Dacarbazine (also known as DTIC) is an intravenously administered alkylating agent used in the therapy of Hodgkin disease and malignant melanoma. Dacarbazine therapy has been associated with serum enzyme elevations during therapy and occasional cases of severe and distinctive acute hepatic failure, probably caused by acute sinusoidal obstruction syndrome.

### Background

Dacarbazine (da kar' ba zeen) is a triazene analogue of 5-aminoimidazole-4-carboxamide, a precursor in purine biosynthesis. Its mechanism of action in cancer chemotherapy is unclear. Dacarbazine may act as a purine analogue and antimetabolite. In addition, it is extensively metabolized in the liver and produces intermediates some of which have alkylating activity, causing methylation, modification and cross linking of DNA, thus inhibiting DNA, RNA and protein synthesis. Dacarbazine is popularly known as DTIC and was approved for use in the United States in 1975. Current indications include Hodgkin lymphoma and metastatic malignant melanoma usually in combination with other antineoplastic agents. Dacarbazine is available for injection in vials of 10 mg/mL and the recommended dose varies by indication and body weight (2 to 4.5 mg/kg/day or 150 mg/m^2^/day). Dacarbazine is given by intravenous infusion typically for five to ten days in cycles of every 3 to 4 weeks. Common side effects are hypotension, alopecia, anoxia, nausea, vomiting, headache, peripheral neuropathy, and flu-like illness. Rare potentially severe adverse events include severe bone marrow suppression, neutropenia, sepsis, embryo-fetal toxicity and de novo cancinogenesis from long term use.

### Hepatotoxicity

Mild and transient elevations in serum aminotransferase levels are not uncommon during courses of systemic combination chemotherapy and the role of dacarbazine in these abnormalities is not clear. However, dose modification for serum enzyme elevations is rarely necessary. More importantly, dacarbazine is associated with a severe and distinctive liver injury which typically arises during the second or third cycle of therapy and most likely represents severe acute sinusoidal obstruction syndrome. Patients typically develop the sudden onset of severe abdominal pain, hemodynamic instability and rapidly rising levels of serum aminotransferase levels and prothrombin time, with death within 1 to 10 days (Cases 1 and 2). Liver biopsy and necropsy findings indicate centrolobular necrosis with occlusion of sinusoids and small and large hepatic veins. In some cases, hepatic infarcts are found as well. Eosinophilic infiltrations are common and peripheral eosinophilia may also be present. Unlike with other alkylating agents, sinusoidal obstruction syndrome caused by dacarbazine is associated with the usual chemotherapy doses, not the higher doses used in myeloablation in preparation for bone marrow transplantation. This syndrome is now rarely reported, probably because of use of dacarbazine in somewhat lower doses.

Likelihood score: B (highly likely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of hepatotoxicity from dacarbazine is not known; however, clinical and pathologic features suggest direct injury to sinusoidal endothelial cells causing their death and extrusion into sinusoids with subsequent obstruction. The injury may be immunologically mediated as it usually occurs with the second or third cycle and is accompanied by eosinophilia. In several cases, the initial cycle of dacarbazine was marked by eosinophilia and fever.

### Outcome and Management

The severity of sinusoidal obstruction syndrome varies considerably, but most published cases have been severe and rapidly fatal. Anecdotal reports suggest that corticosteroids may be beneficial, but many cases have demonstrated fatal hepatic injury by the time of recognition. Rechallenge should not be done. Defibrotide has been approved for treatment of severe sinusoidal obstruction syndrome with solid organ failure in patients undergoing hematopoietic cell transplantation, but has not been specifically approved for the acute liver failure associated with dacarbazine use.

Drug Class: Antineoplastic Agents, Alkylating Agents

## CASE REPORTS

### Case 1. Acute hepatic failure after dacarbazine therapy.

[Modified from: Herishanu Y, Lishner M, Kitay-Cohen Y. The role of glucocorticoids in the treatment of fulminant hepatitis induced by dacarbazine. Anticancer Drugs 2002; 13: 177-9. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/11901312)]

A 69 year old man with malignant melanoma developed fever, epigastric pain and nausea on day 2 of a second 5 day course of dacarbazine (DTIC: 250 mg/m^2^ daily). On examination, he was febrile (39.5 ^o^C) and hypotensive (blood pressure 74/40 mmHg). His abdomen was distended and he had marked right upper quadrant tenderness. There was no jaundice or rash and no peripheral manifestations of chronic liver disease. The white blood cell count was normal without eosinophilia. Liver tests showed a total bilirubin of 1.1 mg/dL, ALT 7040 U/L, AST 6080 U/L, LDH 23,635 U/L, alkaline phosphatase 259 U/L and GGT 159 U/L. Serum creatinine was 2.1 mg/dL, and INR was 1.8. Abdominal ultrasound showed a moderate amount of ascitic fluid and two suspected metastases in the liver (~2.4 cm in diameter). On hospital day 3, the patient developed early hepatic encephalopathy and serum ammonia levels were elevated (95 μmol/L). On day 4, mild hypoglycemia occurred and he was treated with fluids, lactulose, neomycin and intravenous hydrocortisone (300 mg/day). On day 5, he was stuporous, but subsequently he began to improve clinically such that he could be discharged by the hospital day 10. Two weeks later he was minimally symptomatic, had no ascites, and serum enzymes had markedly improved.

#### Key Points

Medication: | Dacarbazine (250 mg/m^2^ daily in 5 day cycles)
Pattern: | Sinusoidal obstruction syndrome (hepatocellular)
Severity: | 4+ (acute liver failure with spontaneous survival)
Latency: | 2 days after starting a second 5 day cycle
Recovery: | 10 days
Other medications: | Interferon-α and previous therapy with chlorambucil and prednisone

#### Comment

Most cases of acute hepatic necrosis due to dacarbazine are rapidly fatal. Typically, the injury arises abruptly during the second course of therapy with sudden onset of fever and abdominal pain followed by cardiovascular collapse and marked rises in serum aminotransferase levels and LDH. Coagulopathy is usually present early, while bilirubin elevations occur later and with progressive hepatic failure (ascites, hepatic encephalopathy). Many cases have a history of mild nausea and fever with peripheral eosinophilia during the first course of therapy, a clinical pattern that also occurs with halothane hepatotoxicity. While the cause of the dacarbazine hepatic injury is believed to be acute sinusoidal obstruction syndrome, other features resemble acute ischemic necrosis due to shock or hepatic infarction. The presence of eosinophilia suggests hypersensitivity which is also supported by the occurrence during reexposure and the history of fever with the initial cycle of treatment. Regardless, the syndrome is severe and corticosteroid therapy is not unreasonable if started early. Furthermore, patients who develop fever and eosinophilia during dacarbazine therapy should not receive a second course.

### Case 2. Acute veno-occlusive disease and liver failure due to dacarbazine.

[Modified from: Ceci G, Bella M, Melissari M, Gabrielli M, Bocchi P, Cocconi G. Fatal hepatic toxicity of DTIC: Is It Really a Rare Event? Cancer 1985; 61: 1988-91. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/3359400)]

A 52 year old man with metastatic malignant melanoma developed fever during day 2 of a second cycle of dacarbazine followed on day 4 by acute abdominal pain and shock. He had tolerated the first cycle of dacarbazine with only mild nausea and vomiting and a few days of fever of 38-39 ^o^C immediately after the 5 day course. At the time of restarting dacarbazine, he was without symptoms and the tumor had decreased in size. On presentation with hepatic injury, he was hypotensive and had tender hepatomegaly. Laboratory tests showed total bilirubin of 2.8 mg/dL, ALT 2050 U/L, AST 2990 U/L, LDH 3270 U/L, alkaline phosphatase 153 U/L, and INR 1.64. Ultrasound of the abdomen showed an enlarged liver and ascites. Acute cholecystitis was suspected and a laparotomy was performed. The gallbladder showed signs of chronic inflammation but no perforation. The liver was enlarged and dark. A liver biopsy showed diffuse centrolobular hepatic necrosis and hemorrhage. After surgery, he developed multiorgan failure and progressive hepatic decompensation, dying on hospital day 8. At autopsy, the liver was enlarged and histology showed centrolobular necrosis and hemorrhage with occlusion of small and medium sized hepatic veins.

#### Key Points

Medication: | Dacarbazine (250 mg/m^2^ for 5 days every 3 weeks)
Pattern: | Hepatocellular ( R=~35)
Severity: | 5+ (fatal)
Latency: | 2 days (fever)
Recovery: | None
Other medications: | Metoclopramide for nausea

#### Comment

The acute hepatic injury attributed to dacarbazine has a very typical clinical presentation and course, with evidence of acute hepatic necrosis as shown by a marked early rise in ALT and LDH with coagulopathy that reverses rapidly if not fatal. The fever and nausea associated with the first course of dacarbazine is typical of subsequent acute liver injury. While the pathology demonstrates sinusoidal obstruction syndrome, there also appears to be an element of acute ischemic necrosis. The rapid appearance on reexposure and the frequent occurrence of fever and eosinophilia suggests a hypersensitivity reaction.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Dacarbazine – Generic, DTIC,® DTIC-Dome®

DRUG CLASS

Antineoplastic Agents, Alkylating Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Dacarbazine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Dacarbazine | 4342-03-4 | C6-H10-N6-O | Dacarbazine Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 10 November 2017

Zimmerman HJ. Oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 673-708. (Expert review of hepatotoxicity of cancer chemotherapeutic agents published in 1999 mentions that dacarbazine has been linked to fatal cases of veno-occlusive disease).
DeLeve LD. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 549-68. (Review of hepatotoxicity of cancer chemotherapeutic agents; mentions that dacarbazine has been implicated in at least 15 cases of sinusoidal obstruction syndrome often associated with eosinophilia).
Chabner BA, Bertino J, Clearly J, Ortiz T, Lane A, Supko JG, Ryan DP. Cytotoxic agents. Chemotherapy of neoplastic diseases. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1315-404. (Textbook of pharmacology and therapeutics).
Frosch PJ, Czarnetzki BM, Macher E, Grundmann E, Gottschalk I. Hepatic failure in a patient treated with dacarbazine (DTIC) for malignant melanoma. J Cancer Res Clin Oncol 1979; 95: 281-6. (55 year old woman with melanoma developed cardiovascular collapse on the third day of second cycle of dacarbazine, with subsequent multiorgan failure and death; autopsy showing ischemic necrosis but evidence of veno-occlusive disease as well). 528568
Houghton AN, Shafi N, Rickles FR. Acute hepatic vein thrombosis occurring during therapy for Hodgkin's disease: a case report. Cancer 1979; 44: 2324-9. (50 year old man with Hodgkin disease developed abdominal pain and fever, followed by cardiovascular collapse on the fifth day of the second course of adriamycin, vinblastine and dacarbazine with bilirubin 1.4 mg/dL, AST 5200 U/L, Alk P 88 U/L, progressing to multiorgan failure and death in 2 days; autopsy showed Budd Chiari syndrome with hepatic vein thrombosis). 509400
Asbury RF, Rosenthal SN, Descalzi ME, Ratcliffe RL, Arseneau JC. Hepatic veno-occlusive disease due to DTIC. Cancer 1980; 45: 2670-4. (59 year old man with melanoma developed fever and nausea 5 days after a 5 day course of dacarbazine which resolved, but then had severe abdominal pain on day 3 of a second cycle [bilirubin 1.6 mg/dL, AST 162 rising to 13,860 U/L, protime 17.3 rising to 30.7 seconds], with death in 2 days; autopsy showing massive centrolobular necrosis). 7379000
Balda BR, Bassermann R. DTIC therapie und Budd-Chiari-Sydrom. Munch Med Wschr 1980; 122: 792-4. (58 year old woman with malignant melanoma developed severe abdominal pain during second cycle of dacarbazine; autopsy showing thrombosis of medium and large hepatic veins with eosinophilic infiltration). 6771598
Runne U, Doepfmer K, Antz H, Groth W, Feaux de Lacrois W. Budd-Chiari-Syndrom unter Dacarbazin. Dtsch Med Wochenschr 1980; 105: 230-3. (50 year old man with malignant melanoma developed shock during second cycle of dacarbazine, with autopsy showing thrombosis of medium and larger veins and eosinophilic infiltration). 6986251
Voigt H, Caselitz J, Jänner M. [Veno-occlusive syndrome with acute liver dystrophy following dacarbazine therapy of malignant melanoma]. Klin Wochenschr 1981; 59: 229-36. German. (68 year old man with malignant melanoma developed cardiovascular collapse during a second course of dacarbazine therapy, with death within 5 days [peak ALT 4950 U/L, LDH 11,059 U/L, GGT 46 U/L]). 7218735
Czarnetzki BM, Macher E. DTIC(dacarbazine)-induced hepatic damage. Possible pathogenesis and prevention. Arch Dermatol Res 1981; 270: 375-6. (71 year old woman with malignant melanoma developed ALT elevations [peak values 96 and 37 U/L] and eosinophilia after first two cycles of dacarbazine, which did not occur with subsequent courses with concurrent prednisone therapy). 6115618
Greenstone MA, Dowd PM, Mikhailidis DP, Scheuer PJ. Hepatic vascular lesions associated with dacarbazine treatment. Br Med J (Clin Res Ed) 1981; 282: 1744-5. (Two cases, 53 and 46 year old men with malignant melanoma, developed liver injury on the third to fourth day of a second course of dacarbazine therapy, dying within 72 hours [patient 1: bilirubin 4.5 mg/dL, ALT 1780 U/L, Alk P 148 U/L], autopsy showing hepatic infarcts). 6786601
Doering CH, Pickartz H, Orfanos CE, Altenahr E. [Dacarbazine in malignant melanoma. Rare, severe side-effect: Budd-Chiari-syndrome]. Z Hautkr 1982; 57: 971-80. German. (54 year old man with melanoma developed fever and eosinophilia during first course and fever and shock during second course of dacarbazine [bilirubin 2.1 mg/dL, ALT 1574 U/L, prothrombin index 23%], dying 11 days later, autopsy showing fresh thromboses in small and medium hepatic veins). 7113323
Swenson-Beck H, Trettel WH. Budd-Chiari-Syndrom bei DTIC-therapie. Hautarzt 1982; 33: 30-1. (41 year old woman with melanoma developed abdominal pain and shock on second day of second course of dacarbazine [ALT >900 U/L, 28% eosinophils], dying within 24 hours, biopsy showed changes suggestive of hepatic vein thrombosis). 7085277
Feaux de Lacroix W, Runne U, Hauk H, Doepfmer K, Groth W, Wacker D. Acute liver dystrophy with thrombosis of hepatic veins: a fatal complication of dacarbazine treatment. Cancer Treat Rep 1983; 67: 779-84. (4 cases of acute liver failure in 50-59 year old patients with malignant melanoma, with shock-like symptoms arising during the second cycle of dacarbazine with rapid progression to death; autopsies showed hemorrhagic necrosis and thrombosis of small hepatic veins, often with eosinophilic infiltrates, some patients having peripheral eosinophilia). 6883354
Dancygier H, Runne U, Leuschner U, Milbradt R, Classen M. Dacarbazine (DTIC)-induced human liver damage: light and electron-microscopic findings. Hepatogastroenterology 1983; 30: 93-5. (61 year old man with malignant melanoma developed severe liver injury during second cycle of dacarbazine, liver biopsy showing centrolobular necrosis and electron microscopy showing intracytoplasmic vacuoles in hepatocyte with membranous blebs; patient recovered on methylprednisolone therapy). 6884975
Sotaniemi EA, Sutinen S, Arranto AJ, Sutinen S, Sotaniemi KA, Lehtola J, Pelkonen RO. Liver damage in nurses handling cytostatic agents. Acta Med Scand 1983; 214: 181-9. (Three nurses developed liver injury after years of handling cytostatic drugs including dacarbazine; they had neurological symptoms associated with elevated ALT and alkaline phosphatase levels; liver histology showed portal hepatitis with piecemeal necrosis in one of them, the others had hepatic fibrosis and fat accumulation). 6660024
Erichsen C, Jönsson PE. Veno-occlusive liver disease after dacarbazine therapy (DTIC) for melanoma. J Surg Oncol 1984; 27: 268-70. (46 year old man with malignant melanoma developed abdominal pain and ascites after a third cycle of dacarbazine [bilirubin 3.1 mg/dL ALT 5282 U/L, Alk P 534 U/L, prothrombin index 12%] and died within days; autopsy showed veno-occlusive disease with eosinophilic infiltrates). 6503301
Leyh F, Winzer M, Weber M, Hypa F. Budd-Chiari syndrome following dacarbazine therapy of malignant melanoma--an avoidable complication? Z Hautkr 1985; 60: 961-72. (51 year old woman with malignant melanoma died of Budd-Chiari syndrome during treatment with dacarbazine). 4024678
Paschke R, Heine M. Pathophysiological aspects of dacarbazine-induced human liver damage. Hepatogastroenterology 1985; 32: 273-5. (39 year old with Hodgkin disease developed hypotension after 4 days of dacarbazine therapy, with rise in ALT to 561 U/L and 21% eosinophilia with ascites and progressive hepatic failure; autopsy showed venoocclusive disease). 4093126
Rollins BJ. Hepatic veno-occlusive disease. Am J Med 1986; 8: 297-306. (Review of the diagnosis, clinical course, histology and pathogenesis of veno-occlusive disease, now known as sinusoidal obstruction syndrome). 3526887
Joensuu H, Soderstrom KO, Nikkanen V. Fatal necrosis of the liver during ABVD chemotherapy for Hodgkin's disease. A case report. Cancer 1986; 58: 1437-40. (50 year old man with Hodgkin lymphoma treated with ABVD [doxorubicin, bleomycin, vinblastine and dacarbazine] at 4 week intervals developed acute liver failure during fourth cycle and autopsy showed centrolobular necrosis). 2427187
Jones RJ, Lee KS, Beschorner WE, Vogel VG, Grochow LB, Braine HG, Vogelsang GB, et al. Veno-occlusive disease of the liver following bone marrow transplantation. Transplantation 1987; 4: 778-83. (Among 235 patients undergoing bone marrow transplantation between 1982 and 1985, sinusoidal obstruction syndrome [SOS] developed in 52 [22%] of whom half died, making SOS the third most common cause of death in this population). 3321587
Ceci G, Bella M, Melissari M, Gabrielli M, Bocchi P, Cocconi G. Fatal hepatic vascular toxicity of DTIC. Is it really a rare event? Cancer 1988; 61: 1988-91. (Among 68 patients with malignant melanoma, 2 developed hepatic failure on dacarbazine therapy; 52 and 70 year old men developed fever and shock during a second cycle of dacarbazine [patient 1: bilirubin 2.8 mg/dL, ALT 2050 U/L, Alk P 153 U/L, INR 1.6], with multiorgan failure and death 1 and 8 days later; autopsies showed massive centrolobular necrosis and occlusion of small hepatic veins and infiltrates of eosinophils: Case 2). 3359400
Marsh JC. Hepatic vascular toxicity of dacarbazine (DTIC): not a rare complication. Hepatology 1989; 9: 790-2. (Summary and comment on article by Ceci [1988]). 2707742
Paschke R, Heine M, Braun S, Usadel KH. Mechanisms of hepatotoxicity caused by dacarbazine in rats. J Cancer Res Clin Oncol 1993; 119: 475-81. (In rats, high doses of dacarbazine cause acute hepatocellular necrosis; no hepatic venous changes or eosinophilia). 8509437
Bearman SI. The syndrome of hepatic veno-occlusive disease after marrow transplantation. Blood 1995; 85: 3005-20. (Review of hepatic veno-occlusive disease after bone marrow transplantation; usually presents with painful hepatomegaly, weight gain [fluid and ascites] and jaundice within 3 weeks of myeloablation, with occlusion of central veins and sinusoids and extensive zone 3 [centrolobular] injury). 7756636
Quinio P, Bouche O, Lambolais C, Savry C, Cartier H, Egreteau JP. Fatal hepatic toxicity of DTIC: a new case. Intens Care Med 1997; 23: 1099-1102. (50 year old woman with malignant melanoma developed abdominal pain and fever on day 2 of the second cycle of dacarbazine [ALT 2348 U/L, LDH 20,430 U/L, INR 3.9], with ascites, multiorgan failure and death 5 days later). 9407248
Herishanu Y, Lishner M, Kitay-Cohen Y. The role of glucocorticoids in the treatment of fulminant hepatitis induced by dacarbazine. Anticancer Drugs 2002; 13: 177-9. (61 year old man with malignant melanoma developed fever and abdominal pain on second day of second cycle of dacarbazine [bilirubin 1.1 mg/dL, ALT 7040 U/L, LDH 23,635 U/L, Alk P 249 U/L, INR 1.8], with ascites, hypotension, and encephalopathy, with improvement after corticosteroid therapy and rapid recovery: Case 1). 11901312
McDonald GB. Hepatobiliary complications of hematopoietic cell transplantation, 40 years on. Hepatology 2010; 51: 1450-60. (Review of liver complications of bone marrow [hematopoietic cell] transplantation, which have become less frequent with better understanding of their causes and means of prevention; the rate of sinusoidal obstruction syndrome has decreased because of avoidance of more aggressive ablative therapies [total body irradiation and high doses of cyclophosphamide] and better understanding of pharmacokinetics of the alkylating agents). 20373370
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, none of which were attributed to dacarbazine). 20949552
García-Del-Muro X, López-Pousa A, Maurel J, Martín J, Martínez-Trufero J, Casado A, Gómez-España A, et al; Spanish Group for Research on Sarcomas. Randomized phase II study comparing gemcitabine plus dacarbazine versus dacarbazine alone in patients with previously treated soft tissue sarcoma: a Spanish Group for Research on Sarcomas study. J Clin Oncol 2011; 29: 2528-33. (Controlled trial of dacarbazine with or without gemcitabine in 113 patients with soft tissue sarcomas; side effects were frequent, but no mention of ALT elevations or clinically apparent liver injury). 21606430
Robert C, Thomas L, Bondarenko I, O'Day S, Weber J, Garbe C, Lebbe C, et al. Ipilimumab plus dacarbazine for previously untreated metastatic melanoma. N Engl J Med 2011; 364: 2517-26. (Controlled trial of dacarbazine with or without ipilimumab [monoclonal anti-CTLA-4] in 502 patients with metastatic melanoma; ALT elevations occurred in 33% of combination versus 6% of dacarbazine alone treated patients and "immune related hepatitis" in 38% on ipilimumab, with no mortality, but delay in resolution averaging 10 weeks). 21639810
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, 40 of which were attributed to antineoplastic agents, but none specifically to dacarbazine). 24552865
Douros A, Bronder E, Andersohn F, Klimpel A, Thomae M, Sarganas G, Kreutz R, et al. Drug-induced liver injury: results from the hospital-based Berlin Case-Control Surveillance Study. Br J Clin Pharmacol 2015; 79: 988-99. (Among 198 patients with hepatitis of uniknown cause enrolled in a prospective database from 51 Berlin hospitals between 2002 and 2011, none were attributed to dacarbazine). 25444550
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 49 cases were attributed to antineoplastic agents, but none to dacarbazine). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Dacarbazine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Dacarbazine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Dacarbazine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Dacarbazine)